# Eluxadoline

## OVERVIEW

### Introduction

Eluxadoline is a mixed opioid receptor agonist (mu) and antagonist (delta) that is used to treat diarrhea-predominant irritable bowel disease. Eluxadoline is associated with a low rate of serum aminotransferase elevations that appear to be due to isolated instances of sphincter of Oddi spasm and/or pancreatitis that occurs most frequently in persons without a gallbladder.

### Background

Eluxadoline (el" ux ad' oh leen) is mixed opioid receptor agonist and antagonist, having agonist activity for the mu (µ) receptor and antagonist activity for the delta (δ) receptor. This combination of activities leads to its activity in reducing bowel transit and decreasing pain without the side effects that occur with mu receptor agonism alone. Eluxadoline is also minimally absorbed and thus does not have the central nervous system effects of typical opiates and does not require DEA restrictions. Several prospective controlled trials have shown that eluxadoline decreases gastrointestinal discomfort and symptoms in patients with diarrhea-predominant irritable bowel syndrome and it was approved for this use in the United States in 2015. Eluxadoline is available in tablets of 75 and 100 mg under the brand name Viberzi. The recommended dose is 100 mg twice daily with dose reduction based upon tolerance. Side effects include constipation, nausea, and abdominal pain. Uncommon, but potentially severe adverse reactions include severe abdominal pain due to spasm of the sphincter of Oddi or pancreatitis, complications that occur mostly in patients without a gallbladder or with preexisting pancreatic or hepatobiliary disease.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations were uncommon during eluxadoline therapy and in pooled analyses ALT elevations above 3 times the upper limit of normal occurred in 2% to 3% of eluxadoline- vs 1% of placebo-treated subjects. More detailed analysis found rare instances of marked ALT and AST elevations with eluxadoline therapy, not seen with placebo treatment. These more marked elevations were sometimes accompanied by abdominal pain and signs of sphincter of Oddi spasm (as can occur with opioid therapy) or pancreatitis. The abnormalities also arose largely in patients without a gallbladder or with a history of pancreatitis or hepato-biliary disease. Subsequent to the approval of eluxadoline and its more widescale use, over a hundred reports of pancreatitis (including 2 deaths) were reported to the Food and Drug Administration and eluxadoline was given a “black box” warning regarding its use in persons without a gallbladder. The clinical features of these reactions have not been well described, but they typically arise within the first few weeks of treatment with severe abdominal pain and vomiting sometimes accompanied by marked ALT and AST elevations with or without increases in amylase and lipase. Jaundice is rare and the liver test abnormalities are most likely due to partial bile duct obstruction. There have been no reports of severe acute hepatitis or acute liver failure attributed to eluxadoline therapy.

Likelihood score: C (probable cause of acute liver injury, likely due to bile duct spasm or obstruction).

### Mechanism of Injury

Eluxadoline is minimally absorbed and unlikely to have direct hepatotoxic effects. Most instances of serum aminotransferase elevations attributed to eluxadoline therapy have been accompanied by evidence of acute pancreatitis or sphincter of Oddi spasm or both.

### Outcome and Management

Eluxadoline has been shown to cause sphincter of Oddi spasm and pancreatitis and its use should be limited to patients with a gallbladder and without known preexisting pancreatitis, hepatobiliary disease or advanced cirrhosis. It should also be avoided in persons who drink alcohol to excess.

Drug Classes: Gastrointestinal Agents, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eluxadoline – Viberzi®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eluxadoline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eluxadoline | 864821-90-9 | C32-H35-N5-O5 | Eluxadoline Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2017

Zimmerman HJ. Laxatives. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 721-3. (Expert review of hepatotoxicity published in 1999 before the availability of eluxadoline).
Pasricha PJ. Treatment of disorders of bowel motility and water flux; antiemetics; agents used in biliary and pancreatic disease. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 983-1008. (Textbook of pharmacology and therapeutics; eluxadoline not discussed).
Shah E, Kim S, Chong K, Lembo A, Pimentel M. Evaluation of harm in the pharmacotherapy of irritable bowel syndrome. Am J Med 2012; 125: 381-93. (Systematic review of adverse side effects of drugs used to treat irritable bowel syndrome, before the availability of eluxadoline). 22444104
Lembo AJ, Lacy BE, Zuckerman MJ, Schey R, Dove LS, Andrae DA, Davenport JM, et al. Eluxadoline for irritable bowel syndrome with diarrhea. N Engl J Med 2016; 374: 242-53. (Among 2427 adults with irritable bowel syndrome with diarrhea who were treated with eluxadoline [75 or 100 mg] or placebo twice daily for 26 or 52 weeks, symptoms improved with drug therapy and adverse events more frequent with eluxadoline included nausea [8% vs 5%], constipation [7% to 9% vs 2.5%] and abdominal pain [6% to 7% vs 4%], and 8 eluxadoline treated patients [0.3%], but no placebo recipient developed pancreatitis; severe adverse events were more frequent in patients with prior cholecystectomy [6.1-12.6% vs 2.7-3.7%], a difference also seen in placebo recipients [8.2% vs 1.7%]). 26789872
Dove LS, Lembo A, Randall CW, Fogel R, Andrae D, Davenport JM, McIntyre G, et al. Eluxadoline benefits patients with irritable bowel syndrome with diarrhea in a phase 2 study. Gastroenterology 2013; 145: 329-38. (Among 807 patients with irritable bowel disease with diarrhea treated with eluxadoline [5, 25, 100 or 200 mg] or placebo twice daily for 12 weeks, symptoms improved with the higher drug doses while overall adverse event rates were similar across groups, although 4 eluxadoline treated patients developed pancreatitis; nevertheless, "results from routine laboratory evaluations…were unremarkable”). 23583433
Traynor K. Eluxadoline approved for irritable bowel syndrome with diarrhea. Am J Health Syst Pharm 2015; 72: 1078. (News report on approval of eluxadoline for irritable bowel disease with diarrhea; mentions its association with occasional cases of pancreatitis). 26092951
Eluxadoline (Viberzi) for irritable bowel syndrome with diarrhea. Med Lett Drugs Ther 2016; 58 (1485): 4-5. (Concise review of the mechanism of action, clinical efficacy, safety and costs of eluxadoline therapy of irritable bowel disease with diarrhea; mentions adverse events of sphincter of Oddi spasm and pancreatitis in patients without a gallbladder or with preexisting hepato-biliary and pancreatic disease). 26714241
Cash BD, Lacy BE, Schoenfeld PS, Dove LS, Covington PS. Safety of eluxadoline in patients with irritable bowel syndrome with diarrhea. Am J Gastroenterol 2017; 112: 365-74. (Safety analysis of pooled data from 2814 patients in 3 placebo controlled clinical trials in irritable bowel syndrome, found side effects more frequent with eluxadoline than placebo to include constipation [7.4% to 8.1% vs 2.4%], nausea [7.1% to 8.1% vs 5%] and 10 episodes [0.6%] of severe abdominal pain suggestive of Sphincter of Oddi spasm usually accompanied by marked elevations in aminotransferase levels, all of which occurred in patients without a gallbladder). 27922029
In brief: Pancreatitis with eluxadoline (Viberzi) in patients without a gallbladder. Med Lett Drugs Ther 2017; 59 (1519): 70. (Brief review of an FDA communication on reports of 118 cases of serious pancreatitis and two fatal instances in patients without a gallbladder who received eluxadoline, stressing the contraindications to its use in patients with preexisting hepatobiliary and pancreatic disease). 28419076

## OTHER REFERENCE LINKS

1. Recent References on Eluxadoline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Eluxadoline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eluxadoline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eluxadoline)